# Pazopanib

## OVERVIEW

### Introduction

Pazopanib is a multi-kinase inhibitor active against vascular endothelial growth factor receptors-1, -2 and -3 that is used in the therapy of advanced renal cell carcinoma and soft tissue sarcomas. Pazopanib therapy is commonly associated with transient elevations in serum aminotransferase during therapy and has been linked to rare, but occasionally severe and even fatal cases of clinically apparent acute liver injury.

### Background

Pazopanib (paz oh’ pa nib) is an orally available, multi-kinase inhibitor, most potently inhibiting the tyrosine kinase receptors of vascular endothelial growth factor (VEGF) 1, 2 and 3 which are associated with tumor growth and angiogenesis. Pazopanib also has activity against c-KIT (an abnormal tyrosine kinase found in gastrointestinal stromal tumors) and the platelet derived growth factor (PDGF) receptor. Clinical trials of pazopanib in malignant diseases in humans have shown activity against renal cell carcinoma and soft tissue sarcoma and promising effects in ovarian and thyroid cancer. Pazopanib received approval for use in the United States in 2012 and current indications include advanced renal cell cancer and soft tissue sarcomas. Pazopanib is available in tablets of 200 mg under the brand name Votrient. The typical dose is 800 mg once daily. Lower doses are recommended for patients with moderate-to-severe liver disease (200 mg daily) and the dose can be reduced to 400 mg daily for toxicity. Common side effects include fatigue, diarrhea, hypertension, hair color changes, anorexia, nausea, and bone marrow suppression. Uncommon, but potentially severe side effects include prolonged QTc intervals, hemorrhages, arterial thrombosis, visceral perforations and fistulae, interstitial lung disease, reversible posterior leukoencephalopathy syndrome, and embryo-fetal toxicity.

### Hepatotoxicity

In large clinical trials, abnormalities in routine liver tests were common in patients treated with pazopanib, with serum aminotransferase elevations occurring in up to half of patients and total serum bilirubin in approximately one-third. ALT and AST values greater than 5 times the upper limit of normal (ULN) occurred in 8% of patients and combinations of ALT and bilirubin elevations in 1% to 2%. In preliminary trials of pazopanib in various solid tumors, there were rare reports of hepatitis with jaundice in <1% of patients. Subsequently, fatal instances of liver injury have been reported and the clinical features of the hepatotoxicity have been better defined. The clinical onset is typically within 4 to 12 weeks of starting pazopanib and the pattern of serum enzyme elevations is usually mixed. Immunoallergic and autoimmune features are not present. The course is typically self-limited, but can be prolonged and severe and fatal instances have been reported (Case 1).

Likelihood score: C (probable cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of injury accounting for serum enzyme elevations during pazopanib therapy is not known. Retrospective analyses and genetic studies have suggested that other medications (simvastatin) and HFE polymorphisms may play a role in serum aminotransferase elevations and Gilbert syndrome in hyperbilirubinemia. Pazopanib is metabolized in the liver largely through the CYP 3A4 pathway and liver injury may be related to production of a toxic intermediate. Pazopanib is susceptible to drug-drug interactions with agents that inhibit or induce hepatic CYP 3A4 activity.

### Outcome and Management

Liver test abnormalities are frequent during pazopanib therapy and routine monitoring is recommended at 3 to 4 week intervals. Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) or any elevations accompanied by jaundice or symptoms should lead to dose reduction or temporary cessation. There does not appear to be cross reactivity in risk for hepatic injury between pazopanib and other kinase inhibitors and, in some situations, switching to another tyrosine kinase receptor inhibitor may be appropriate.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

## CASE REPORT

### Case 1. Severe acute liver injury and hepatic failure due to pazopanib.(1)

A 77 year old man with metastatic renal cell carcinoma developed jaundice 6 weeks after starting pazopanib (800 mg daily). He had no previous history of liver disease and had normal routine liver tests before therapy and after 2 weeks of treatment (Table). He had no risk factors for viral hepatitis or history of alcohol abuse and was taking no other potentially hepatotoxic medications. On presentation, serum bilirubin was 6.3 mg/dL, ALT 759 U/L, AST 296 U/L and alkaline phosphatase 729 U/L. Pazopanib was stopped promptly and he was monitored closely. Tests for viral hepatitis A, B and C and cytomegalovirus infection were negative as were routine autoantibodies. A liver biopsy showed acute cholestatic hepatitis with mild bile duct injury. While serum aminotransferase levels rapidly fell to near normal levels, serum alkaline phosphatase remained high and bilirubin levels rose. Four weeks after presentation, the prothrombin time began to rise and the patient died of hepatic failure approximately 9 weeks after initial presentation.

#### Key Points

Medication: | Pazopanib (800 mg daily)
Pattern: | Mixed (R=~3: normal values not provided)
Severity: | 5+ (hepatic failure and death)
Latency: | 6 weeks
Recovery: | None
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | Pre | 25 | 100 | 0.2
0 | Pre | 22 | 98 | 0.2 | Pazopanib started
2 weeks | Pre | 30 | 89 | 0.3 | INR 1.1
6 weeks | 0 | 759 | 729 | 6.3 | Pazopanib stopped
7 weeks | 1 | 166 | 523 | 10.4 | INR 1.1
8 weeks | 2 weeks | 55 | 426 | 15.7 | Liver biopsy
9 weeks | 3 weeks | 38 | 381 | 22.9
10 weeks | 4 weeks | 34 | 437 | 18.6 | INR 1.8
11 weeks | 5 weeks | 29 | 484 | 14.9 | INR 1.7
15 weeks | 9 weeks | 28 | 484 | 13.0 | Death
Normal Values | | Not given | Not given | <1.2

#### Comment

Elevations in serum aminotransferase levels occur in up to 50% of patients treated with pazopanib and rise to above 5 times ULN (approximately 200 U/L) in 8% of patients. Regular monitoring of liver tests is recommended. In this patient, monitoring of liver enzymes was done, but he presented with clinically apparent liver injury despite such monitoring and progressed to hepatic failure despite prompt discontinuation of therapy. The initial pattern of liver enzyme elevations was mixed, with prominent elevations in both serum aminotransferase and alkaline phosphatase levels. Subsequently, serum ALT levels fell, but alkaline phosphatase levels remained high and bilirubin levels continued to rise. A liver biopsy was done that reportedly showed active cholestatic hepatitis with some degree of bile duct injury and ductular proliferation. Within a few weeks, signs of hepatic failure arose and the patient died 9 weeks after presentation with what might be considered a subacute hepatic failure. The patient’s age and other comorbidities may have contributed to the poor outcome. A second patient (62 year old man) described in this report had a similar presentation with a mixed pattern of serum enzymes (ALT 935 U/L, Alk P 784 U/L) and jaundice (bilirubin 3.7 mg/dL), but had spontaneous improvement starting 3 weeks after stopping pazopanib and ultimate complete recovery.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Pazopanib – Votrient®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Pazopanib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Pazopanib | 444731-52-6 | C21-H23-N7-O2-S

## CITED REFERENCE

1 Klempner SJ, Choueiri TK, Yee E, Doyle LA, Schuppan D, Atkins MB. (2012). Severe pazopanib-induced hepatotoxicity: clinical and histologic course in two patients. J Clin Oncol.

## ANNOTATED BIBLIOGRAPHY

References updated: 10 May 2020

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase inhibitors such as pazopanib).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents discusses several tyrosine kinase inhibitors including imatinib, gefitinib, erlotinib and crizotinib, but not pazopanib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
Sleijfer S, Ray-Coquard I, Papai Z, Le Cesne A, Scurr M, Schöki P, Collin F, et al. (2009). Pazopanib, a multikinase angiogenesis inhibitor, in patients with relapsed or refractory advanced soft tissue sarcoma: a phase II study from the European organisation for research and treatment of cancer-soft tissue and bone sarcoma group (EORTC study 62043). J Clin Oncol. (Among 142 patients with advanced soft tissue sarcomas, pazopanib demonstrated "interesting activity" and side effects included anemia [75%], leucopenia [42%], thrombocytopenia [10%], hypertension [40%], fatigue [37%], diarrhea [30%], nausea [36%], and elevations in ALT [50%], bilirubin [38%] and creatinine [26%]).
Xu CF, Reck BH, Xue Z, Huang L, Baker KL, Chen M, Chen EP, et al. (2010). Pazopanib-induced hyperbilirubinemia is associated with Gilbert's syndrome UGT1A1 polymorphism. Br J Cancer. (Among 246 patients with cancer treated with pazopanib, analysis of genetic polymorphisms of 11 candidate genes found an association of hyperbilirubinemia with the gene for Gilbert syndrome).
Sternberg CN, Davis ID, Mardiak J, Szczylik C, Lee E, Wagstaff J, Barrios CH, et al. (2010). Pazopanib in locally advanced or metastatic renal cell carcinoma: results of a randomized phase III trial. J Clin Oncol. (Among 435 patients with advanced renal cell cancer, objective tumor responses occurred in 30% of pazopanib vs 3% of placebo recipients, but side effects were common including ALT increases in 53% [ ≥5 times ULN in 12%], diarrhea [52%], hypertension [40%], hair color change [38%], nausea [26%], thrombotic events [3%], and one patient died of hepatic failure).
(2010). Everolimus and pazopanib: two new drugs for renal cell cancer. Med Lett Drugs Ther. (Concise summary of efficacy, safety and costs of pazopanib shortly after its approval for use in the US; mentions "the possibility of severe and fatal hepatotoxicity" and recommendation to monitor liver tests closely).
Bukowski RM, Yasothan U, Kirkpatrick P. (2010). Pazopanib. Nat Rev Drug Discov. (Brief summary of history of development of pazopanib, its mechanism of action, clinical indications and place in "the market", mentions that pazopanib is associated with side effects of hepatic toxicity).
Xu CF, Reck BH, Goodman VL, Xue Z, Huang L, Barnes MR, Koshy B, et al. (2011). Association of the hemochromatosis gene with pazopanib-induced transaminase elevation in renal cell carcinoma. J Hepatol. (Analysis of 6852 genetic polymorphisms among 242 patients with cancer treated with pazopanib identified 92 polymorphisms in 40 genes associated with ALT elevations and focused upon two markers in the HFE gene).
Keisner SV, Shah SR. (2011). Pazopanib: the newest tyrosine kinase inhibitor for the treatment of advanced or metastatic renal cell carcinoma. Drugs. (Review of mechanism of action, efficacy and safety of pazopanib therapy of renal cell cancer lists side effects including elevations in ALT in 53% of patients [ ≥5 times ULN in 12%] and bilirubin in 36% [ ≥3 times ULN in 4%]).
Xu CF, Xue Z, Bing N, King KS, McCann LA, de Souza PL, Goodman VL, et al. (2012). Concomitant use of pazopanib and simvastatin increases the risk of transaminase elevations in patients with cancer. Ann Oncol. (Retrospective analysis of ALT elevations [ ≥3 times ULN] in 976 patients on pazopanib found higher rate in those also taking simvastatin [27%] and atorvastatin [17%] compared to those not on a statin [14%]).
Klempner SJ, Choueiri TK, Yee E, Doyle LA, Schuppan D, Atkins MB. (2012). Severe pazopanib-induced hepatotoxicity: clinical and histologic course in two patients. J Clin Oncol. (Two patients, 77 and 62 year old men with renal cell cancer developed jaundice 4-6 weeks after starting pazopanib [peak bilirubin 22.9 and 4.5 mg/dL, ALT 759 and 935 U/L, Alk P 729 and 784 U/L], one dying of hepatic failure and one recovering within 3 months of stopping: Case 1).
Motzer RJ, Johnson T, Choueiri TK, Deen KC, Xue Z, Pandite LN, Carpenter C, Xu CF. (2013). Hyperbilirubinemia in pazopanib- or sunitinib-treated patients in COMPARZ is associated with UGT1A1 polymorphisms. Ann Oncol. (Among 1110 patients with renal cell cancer treated with tyrosine kinase inhibitors, bilirubin elevations ≥1.5 times ULN occurred in 16% on pazopanib vs 9% on sunitinib, and the accumulated rate of the elevations was higher in patients who were homozygous for the UGT1A1 polymorphisms of Gilbert syndrome).
Shibata SI, Chung V, Synold TW, Longmate JA, Suttle AB, Ottesen LH, Lenz HJ, et al. (2013). Phase I study of pazopanib in patients with advanced solid tumors and hepatic dysfunction: a National Cancer Institute Organ Dysfunction Working Group study. Clin Cancer Res. (Among 98 patients with advanced solid tumors and varying degrees of liver dysfunction treated with varying doses of pazopanib, found the poor tolerance of standard doses among patients with moderate-to-severe liver dysfunction was not due to decrease in drug clearance).
Kapadia S, Hapani S, Choueiri TK, Wu S. (2013). Risk of liver toxicity with the angiogenesis inhibitor pazopanib in cancer patients. Acta Oncol. (Systematic review of hepatic toxicity of pazopanib based upon 10 clinical trials with 1478 patients calculated rate of ALT elevations as 41% [ ≥5 times ULN in 9%] and bilirubin 25% [ ≥3 times ULN 3%], with only 2 cases of fatal hepatic failure).
Spraggs CF, Xu CF, Hunt CM. (2013). Genetic characterization to improve interpretation and clinical management of hepatotoxicity caused by tyrosine kinase inhibitors. Pharmacogenomics. (Review of genetic associations of serum ALT and bilirubin elevations during therapy with tyrosine kinase inhibitors focusing on lapatinib and pazopanib).
Shah RR, Morganroth J, Shah DR. (2013). Hepatotoxicity of tyrosine kinase inhibitors: clinical and regulatory perspectives. Drug Saf. (Review of the hepatotoxicity of 18 tyrosine kinase inhibitors approved for use in cancer in the US as of 2013 mentions that cases of acute hepatitis and fatal hepatic failure have been described in patients receiving pazopanib and that aminotransferase elevations occur in 46-53% of patients [ ≥5 times ULN in 7-12%], generally within the first 18 weeks of treatment).
Teo YL, Ho HK, Chan A. (2013). Risk of tyrosine kinase inhibitors-induced hepatotoxicity in cancer patients: a meta-analysis. Cancer Treat Rev. (Combined analysis of 12 placebo controlled trials of various tyrosine kinase inhibitors found a higher rate of ALT elevations with kinase inhibitors than with placebo).
Bible KC, Suman VJ, Molina JR, Smallridge RC, Maples WJ, Menefee ME, Rubin J, et al., Endocrine Malignancies Disease Oriented Group. (2014). Mayo Clinic Cancer Center, and the Mayo Phase 2 Consortium. A multicenter phase 2 trial of pazopanib in metastatic and progressive medullary thyroid carcinoma: MC057H. J Clin Endocrinol Metab. (Among 35 patients with advanced medullary thyroid cancer treated with pazopanib for 1-43 months, liver test abnormalities occurred in 6%).
Vlenterie M, van Erp NP, van der Graaf WT. (2015). Promising management of pazopanib-induced liver toxicity. Acta Oncol. (47 year old man and 55 year old woman with synovial sarcoma developed ALT elevations without jaundice 7 and 5 weeks after starting pazopanib [ALT ~400 and 330 U/L] which improved on stopping but rose again [~450 U/L] when pazopanib was restarted, but by adding prednisone therapy [30 mg daily] they were both able to continue pazopanib and ALT levels were maintained at <100 U/L with tapering doses of corticosteroids).
Powles T, Bracarda S, Chen M, Norry E, Compton N, Heise M, Hutson T, et al. (2015). Characterisation of liver chemistry abnormalities associated with pazopanib monotherapy: a systematic review and meta-analysis of clinical trials in advanced cancer patients. Eur J Cancer. (Metaanalysis of liver test abnormalities from 2080 patients enrolled in 9 prospective trials of pazopanib for renal cell cancer, soft tissue sarcoma or ovarian carcinoma found that 20% of subjects developed ALT elevations above 3 times ULN and 6% above 10 times ULN, median onset by 42 days and most within 4 months, normally resolving within 30 days, recurrence on rechallenge in 38% [39 of 103 patients] and only 9 patients [0.4%] had clinically apparent liver injury with jaundice, none developed acute liver failure).
Karczmarek-Borowska B, Sałek-Zań A. (2015). Hepatotoxicity of molecular targeted therapy. Contemp Oncol (Pozn). (Review of hepatotoxicity of modern molecular targeted therapies including monoclonal antibodies, protein kinase inhibitors and proteasome inhibitors; mentions that pazopanib has an increased risk of liver injury).
Xu CF, Johnson T, Wang X, Carpenter C, Graves AP, Warren L, Xue Z, et al. (2016). HLA-B*57:01 confers susceptibility to pazopanib-associated liver injury in patients with cancer. Clin Cancer Res. (Genome wide association studies done on 1,188 patients with cancer treated with pazopanib found that carriers of HLA-B*57:01 had higher rates of ALT elevations than noncarriers, 31% vs 19% above 3 times ULN and 18% vs 10% above 5 times ULN, but accounted for only 10% of cases).
Shantakumar S, Nordstrom BL, Djousse L, Hall SA, Gagnon DR, Fraeman KH, van Herk-Sukel M, et al. (2016). Occurrence of hepatotoxicity with pazopanib and other anti-VEGF treatments for renal cell carcinoma: an observational study utilizing a distributed database network. Cancer Chemother Pharmacol. (Analysis of two electronic medical databases on patients with renal cell cancer identified 352 who were treated with pazopanib, of whom 30 [8.5%] developed ALT elevations above 3 times ULN, but none developed clinically apparent liver injury with jaundice).
Verschoor AJ, Warmerdam FARM, Bosse T, Bovée JVMG, Gelderblom H. (2018). A remarkable response to pazopanib, despite recurrent liver toxicity, in a patient with a high grade endometrial stromal sarcoma, a case report. BMC Cancer. (40 year old woman with metastatic soft tissue sarcoma had a clinical response to pazopanib but developed serum ALT elevations which recurred on rechallenge, but using a lower dose allowed for continuation of therapy).
Okamura Y, Hinata N, Terakawa T, Furukawa J, Harada K, Nakano Y, Nakamura I, et al. (2019). External validation of nomograms for prediction of progression-free survival and liver toxicity in patients with advanced renal cell carcinoma treated with pazopanib. Int J Clin Oncol. (Among 150 Japanese patients with renal cell carcinoma treated with pazopanib, 17% developed ALT elevations which were above 5 times ULN in 7%).
Patel T, Tarun T, Hudhud D, Krvavac A. (2019). Novel Use of N-acetylcysteine in management of tyrosine kinase inhibitor induced acute liver injury. Cureus. (67 year old woman with metastatic angiosarcoma developed fatigue two weeks after starting “high dose” pazopanib [bilirubin 1.5 mg/dL, ALT 1377 U/L, Alk P 275 U/L] who improved somewhat over the next 4 days after stopping therapy and receiving infusions of N-acetylcysteine).

## OTHER REFERENCE LINKS

1 Recent References on Pazopanib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Pazopanib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Pazopanib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Pazopanib)